# Polatuzumab Vedotin

## OVERVIEW

### Introduction

Polatuzumab vedotin is a humanized monoclonal antibody conjugate which is used in the therapy of diffuse large B cell or high grade B cell lymphomas. Polatuzumab vedotin has been linked to transient mild-to-moderate serum enzyme elevations during therapy but has not been implicated in cases of clinically apparent liver injury with jaundice.

### Background

Polatuzumab (pol” a tooz’ ue mab) vedotin (ve doe’ tin) is a humanized monoclonal antibody to the human CD79b cell surface marker which is highly expressed on rapidly dividing B cells and B cell precursors. The monoclonal antibody is conjugated using a linker sequence to a cytotoxic molecule, vedotin, a small molecule anti-mitotic agent also known as monomethyl auristatin E (MMAE). When polatuzumab vedotin binds to CD7b, it is internalized and the vedotin is released by the action of lysosomal enzymes which cleave the short linker molecule that joins the antibody and the cytotoxic molecule. The intracellular vedotin binds to microtubules preventing their participation in cell division resulting in apoptotic cell death of the rapidly dividing malignant B cells. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in adults with diffuse large B cell and high grade B cell lymphomas when given with rituximab-based chemotherapeutic regimens and was given accelerated approval for these indications in the United States in 2019. Polatuzumab vedotin is available in powder for reconstitution in single dose vials of 30 and 140 mg under the brand name Polivy. The typical recommended dose regimen is 1.8 mg/kg administered by intravenous infusion once every 21 days for 6 cycles. Premedication before each infusion with antihistamines and antipyretics is recommended. Polatuzumab vedotin is given in combination with rituximab, cyclophosphamide, doxorubicin, and prednisone (R-CHP) for previously untreated diffuse large B cell and high-grade B cell lymphomas and in combination with rituximab and bendamustine for relapsed or refractory diffuse large B cell lymphoma. Side effects are common with these regimens, not all of which are due to the polatuzumab. Adverse effects may include infusion reactions, nausea, abdominal pain, anorexia, weakness, fatigue, headache, itching and rash. Less common, but potentially serious side effects included peripheral neuropathy, hypersensitivity reactions, severe myelosuppression, serious opportunistic infections, progressive multifocal leukoencephalopathy, tumor lysis syndrome, hepatotoxicity, and embryo-fetal toxicity. Polatuzumab vedotin should be administered only by physicians and health care providers with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In publications of the initial registration trials of polatuzumab vedotin, rates of serum aminotransferase and bilirubin elevations were not provided. In the FDA multidiscipline review of an expanded safety population, however, cases of marked serum aminotransferase elevations arose in 3.8% of recipients of polatuzumab vedotin and of concurrent elevations of serum aminotransferase and bilirubin levels in 2.3%. However, other causes of the abnormalities were often found. Nevertheless, monitoring of serum enzymes and bilirubin is recommended in the product label. After its approval and more widespread use, there have been no instances of clinically apparent liver injury reported in the literature, but instances of suspected liver injury from polatuzumab vedotin have been reported to the FDA.

Because polatuzumab is an immunosuppressive agent with specific activity against B cells, it may pose a risk for reactivation of viral infections including hepatitis B. While there were no reports of hepatitis B virus (HBV) reactivation in the preregistration trials of polatuzumab vedotin, patients with known chronic HBV infection were excluded from enrollment.

Likelihood score: E* (suspected but unproven cause of clinically significant liver injury and possibly reactivation of hepatitis B).

### Mechanism of Injury

The cause of the serum aminotransferase elevations during polatuzumab vedotin therapy is not known, but it is likely due to direct toxicity of the vedotin conjugate rather than the monoclonal antibody. Because polatuzumab is given with multiple other cytotoxic antineoplastic agents (such as rituximab, cyclophosphamide and doxorubicin or bendamustine), the liver test abnormalities may be due to the other agents being used.

### Outcome and Management

The serum aminotransferase elevations that occur during polatuzumab vedotin therapy are generally transient, mild and asymptomatic and do not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal, if detected, should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. Elevations above 20 times the ULN or any elevation accompanied by jaundice or symptoms should lead to prompt permanent discontinuation. Because polatuzumab vedotin is at least theoretically capable of inducing reactivation of hepatitis B, it is appropriate to test patients for HBsAg and anti-HBc before initiating therapy, and if markers are present, monitoring patients for HBV markers (HBV DNA, HBsAg) regularly or providing prophylaxis with antiviral agents active against HBV (tenofovir or entecavir) during therapy.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Polatuzumab Vedotin – Polivy®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Polatuzumab%20Vedotin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Polatuzumab Vedotin | 1313206-42-6 (https://pubchem.ncbi.nlm.nih.gov/compound/Polatuzumab-Vedotin) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Abbreviations used: DLBCL, diffuse large B cell lymphoma.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761121Orig1s000SumR.pdf (FDA website with product labels and initial multidiscipline review of polatuzumab vedotin mentions that the most common side effects were diarrhea, nausea and vomiting, decreased appetite, neutropenia, thrombocytopenia, anemia, peripheral neuropathy, fever and fatigue, and in the registration placebo controlled trial ALT elevations occurred in 38% of patients [none above 5 times ULN] receiving polatuzumab vedotin combined with bendamustine and rituximab compared to 8% [3% above 5 times ULN] on bendamustine and rituximab alone, but in an extended safety cohort of 173 patients cases of marked ALT elevations arose in 3% to 4% of treated patient some of whom had concurrent bilirubin elevations which led to the recommendation for monitoring of routine liver tests during therapy).
Morschhauser F, Flinn IW, Advani R, Sehn LH, Diefenbach C, Kolibaba K, Press OW, et al. Polatuzumab vedotin or pinatuzumab vedotin plus rituximab in patients with relapsed or refractory non-Hodgkin lymphoma: final results from a phase 2 randomised study (ROMULUS). Lancet Haematol. 2019;6:e254-e265. (Among 81 patients with refractory or relapsed diffuse large B cell lymphoma or follicular lymphoma treated with rituximab and either polatuzumab vedotin or pinatuzumab vedotin every 21 days for up to one year, the objective response rates ranged from 54-60% and complete response rates from 21-26%, while the most common adverse events were fatigue [54%], diarrhea [37%], nausea [35%], neutropenia [28%], and peripheral neuropathy [20%]; no mention of ALT elevations or hepatotoxicity). 30935953
Sehn LH, Herrera AF, Flowers CR, Kamdar MK, McMillan A, Hertzberg M, Assouline S, et al. Polatuzumab vedotin in relapsed or refractory diffuse large B-cell lymphoma. J Clin Oncol. 2020;38:155-165. (Among 80 adults with refractory or relapsed diffuse large B cell lymphoma treated with bendamustine and rituximab with or without polatuzumab vedotin, complete response rates were higher with the addition of the conjugated monoclonal [40% vs 17.5%] as was progression-free survival, while adverse side effects of myelosuppression and peripheral neuropathy were also higher; no mention of ALT elevations or hepatotoxicity). 31693429
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector-based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload], including nine that are FDA approved and six others in pivotal trials). 32937862
Segman Y, Ribakovsky E, Avigdor A, Goldhecht Y, Vainstein V, Goldschmidt N, Harlev S, et al. Outcome of relapsed/refractory diffuse large B-cell lymphoma patients treated with polatuzumab vedotin-based therapy: real-life experience. Leuk Lymphoma. 2021;62:118-124. (Among 47 patients with relapsed or refractory aggressive B cell lymphomas treated with a polatuzumab based regimen in 14 Israeli medical centers, the overall and complete response rates were 61% and 40% and overall median survival 8 months; the most common adverse events included cytopenias and peripheral neuropathy; no mention of hepatotoxicity or ALT elevations). 32981410
Smith SD, Lopedote P, Samara Y, Mei M, Herrera AF, Winter AM, Hill BT, et al. Polatuzumab vedotin for relapsed/refractory aggressive B-cell lymphoma: a multicenter post-marketing analysis. Clin Lymphoma Myeloma Leuk. 2021;21:170-175. (Among 69 patients with relapsed or refractory B cell lymphomas treated in 5 US medical centers, the overall and complete response rates [50% and 21%] were lower than reported from clinical trials and median survival was only 5 months; no mention of hepatotoxicity or rates of ALT elevations). 33431309
Tilly H, Morschhauser F, Sehn LH, Friedberg JW, Trněný M, Sharman JP, Herbaux C, et al. Polatuzumab vedotin in previously untreated diffuse large B-cell lymphoma. N Engl J Med. 2022;386:351-363. (Among 879 patients with previously untreated diffuse large B cell lymphoma treated with rituximab, cyclophosphamide, doxorubicin and prednisone and either vincristine [R-CHOP] or polatuzumab vedotin [Pola-R-CHP], progression-free survival was greater with Pola-R-CHP than R-CHOP, but 2 year survival rates and overall safety profiles were similar; no mention of ALT elevations or hepatotoxicity). 34904799
Fu Z, Gao C, Wu T, Wang L, Li S, Zhang Y, Shi C. Peripheral neuropathy associated with monomethyl auristatin E-based antibody-drug conjugates. iScience. 2023;26:107778. (Rates of peripheral neuropathy are higher with antineoplastic monoclonal antibody conjugates with microtubule inhibitors such as vedotin compared to other cytotoxins, overall rates ranging from 8-66%, severe rates from <1% to 12%, caused probably by release of the monomethyl auristatin E toxin from the targeted cells to the systemic circulation or by direct uptake of the monoclonal conjugate by peripheral nerve Schwann cells). 37727735
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023 Oct 29:1-12. Epub ahead of print. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Polatuzumab Vedotin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Polatuzumab+AND+Vedotin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Polatuzumab Vedotin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Polatuzumab%20Vedotin)